# Bee Products: Beeswax, Bee Pollen, Propolis

## OVERVIEW

### Introduction

Products made by bees that are used in alternative medicine include honey, beeswax, bee pollen, propolis and royal jelly. These natural substances have several uses, for both bees and humans, as foods, sealants, lubricants, construction material and medications. Beeswax is a secreted oily solution used by bees to build the honeycomb. Bee pollen is the mixture of various pollens collected by bees to make honey. Propolis is a mixture of beeswax and other oils and resins collected by bees and used in construction of the bee hive and in preserving honey and other perishables. Royal jelly is a secreted milky substance used to feed larvae. When used for medical purposes the products are referred to as apitherapy. The products are generally well tolerated and there is no evidence that they cause liver injury, either in the form of ALT elevations or clinically apparent liver injury.

### Background

Bees make a variety of products that they use as food, for production of honey, in construction and repair of the hive and as sealants to prevent spoilage.

Beeswax (cera alba) is the natural wax produced in the abdominal segments of worker bees which is secreted and deposited in scales and then collected and used to build the honey comb for storage of honey and protection of larvae in the hive. Beeswax consists largely of fatty acid esters of long-chain alcohols. Beeswax has been used by humans for centuries as a lubricant, glaze or polishing solution or waterproofing gel. Beeswax is edible, but is usually combined with other ingredients or used as a covering for products such as cheese for preservation and prevention of mold or fungal contamination.

Bee pollen is the mixture of plant and flower pollen with nectar and saliva that is used in honey production by bees. The pollen is collected by placing traps in the bee hive that knocks off some of the pollen collected by the bees. Its composition is highly variable but includes vitamins, minerals and carbohydrates. Bee pollen is sold as a dietary supplement and is claimed to have antiinflammatory and antibacterial activity. Bee pollen is purported to be beneficial for cancer, arthritis and to improve athletic performance, but has not been shown to have these activities. Bee pollen has been reported to cause allergic reactions in patients with asthma, atopic dermatitis and with allergies to pollen.

Propolis is a natural resinous product that is collected by bees from various plants and mixed with beeswax and salivary enzymes. Propolis is hard and breakable in cold temperatures but soft, flexible and sticky when warmed, so that it can be used to fill gaps, close holes and build the beehive. The sealant action of propolis protects the hive from microorganisms, spores and mold. Propolis has been used by humans topically for treatment of wounds, skin ulcers and rashes and in oral forms as therapy of diabetes, obesity, cancer and other conditions. Propolis is purported to have antiinflammatory, antioxidant, antidiabetic and even antineoplastic activity based upon studies in cell culture and animal models of diseases such as diabetes, obesity and cancer. None of these activities have been convincingly shown in humans with diabetes, obesity or cancer. In most clinical trials, adverse event rates have not been mentioned, but propolis is reported to be well tolerated. Propolis, like bee pollen, is highly variable with chemical compositions that differ markedly by genus of bees and geographic location (based upon local plant species). Propolis may contain contaminants, insect parts and allergens from the environment. Contact dermatitis from propolis is a well known complication of bee-keeping and can occur with topical and oral administration of propolis. Allergic reactions including angioedema and anaphylaxis from commercial sources of propolis have been reported. The allergic reactions are likely due to plant flavonoid aglycones.

Royal jelly is a milk-like secretion from the mandibular glands of worker bees that is used to feed larvae of workers and drones and, when given in larger amounts and for extended periods, for feeding and development of queen bees (fertile females). Royal jelly is collected from individual cells of queen bees and is frequently used in alternative and traditional medicine as is described in further detail in a separate chapter (Royal Jelly).

### Hepatotoxicity

Liver injury attributable to bees products has not been reported. In clinical trials of beeswax and propolis as therapy of diabetes, obesity and cancer, side effects were rarely mentioned and ALT elevations and hepatotoxicity were not reported. Despite their availability and widespread use as an alternative therapies, there have been no published reports of liver injury attributed to bee products.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Bee products such as beeswax, bee pollen and propolis have many components, but none of them has been shown to be particularly hepatotoxic.

### Outcome and Management

Hepatotoxicity from bee products has not been reported.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Beeswax – Generic

Bee pollen – Generic

Propolis – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/78.html) [Bee Pollen]

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Beeswax | 8012-89-3 | Apitherapy | Not Applicable
Propolis | 9009-62-5 | Apitherapy | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: May 1, 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not bee products).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of bee products).
Hausen BM, Wollenweber E, Senff H, Post B. (1987). Propolis allergy. (I). Origin, properties, usage and literature review. Contact Dermatitis. (Review of the clinical features of propolis contact dermatitis, nearly 200 cases of which have been described in the literature).
Hausen BM, Wollenweber E, Senff H, Post B. (1987). Propolis allergy. (II). The sensitizing properties of 1,1-dimethylallyl caffeic acid ester. Contact Dermatitis. (Analysis of the sensitizing properties of constituents of propolis suggested that the hypersensitivity reactions are due to flavonoid aglycones found in buds of poplar trees, possibly dimethylallyl caffeic acid ester).
Greenberger PA, Flais MJ. (2001). Bee pollen-induced anaphylactic reaction in an unknowingly sensitized subject. Ann Allergy Asthma Immunol. (56 year old woman with a history of allergic rhinitis and previous desensitization developed urticaria, pruritus, dyspnea and throat tightness within minutes of drinking a “smoothie” that included bee pollen, analysis of which demonstrated ragweed pollen).
Cohen HA, Varsano I. (2004). Kah an E, Sarrell EM, Uziel Y. Effectiveness of an herbal preparation containing echinacea, propolis, and vitamin C in preventing respiratory tract infections in children: a randomized, double-blind, placebo-controlled, multicenter study. Arch Pediatr Adolesc Med. (Among 430 children, ages 1 to 5 years, treated with an herbal extract containing propolis, echinacea and vitamin C [Chizukit] or placebo twice daily for 6 months, respiratory illnesses were less frequent with Chizukit and adverse events were infrequent [4.2%], mild and mostly consistent with gastrointestinal intolerance).
Menniti-Ippolito F, Mazzanti G, Santuccio C, Moro PA, Calapai G, Firenzuoli F, Valeri A, et al. (2008). Surveillance of suspected adverse reactions to natural health products in Italy. Pharmacoepidemiol Drug Saf. (Among 223 spontaneous reports of adverse reactions to natural products reported over a 5 year period to an Italian national registry, 14 were attributed to propolis, 12 of which were allergic reactions, 4 requiring hospitalization).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found none attributed to beeswax, bee pollen, royal jelly or propolis).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not bee products).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements does not include any attributed to bee products).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but none were attributed to bee products).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss bee products).
Lambrinoudaki I, Augoulea A, Rizos D, Politi M, Tsoltos N, Moros M, Chinou I, et al. (2016). Greek-origin royal jelly improves the lipid profile of postmenopausal women. Gynecol Endocrinol. (Among 36 postmenopausal women treated with oral royal jelly [150 mg] daily for 3 months, serum HDL cholesterol levels increased [60 to 65 mg/dL] while LDL cholesterol decreased slightly [144 to 136 mg/dL]; no mention of adverse events or changes in serum ALT levels).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to bee products).
Sharif SN, Darsareh F. (2019). Effect of royal jelly on menopausal symptoms: A randomized placebo-controlled clinical trial. Complement Ther Clin Pract. (Among 200 postmenopausal woman treated with royal jelly [1000 mg] or placebo once daily for 8 weeks, menopausal symptoms improved with royal jelly therapy but not placebo; no mention of adverse events).
Afsharpour F, Javadi M, Hashemipour S, Koushan Y, Haghighian HK. (2019). Propolis supplementation improves glycemic and antioxidant status in patients with type 2 diabetes: a randomized, double-blind, placebo-controlled study. Complement Ther Med. (Among 60 patients with diabetes treated with propolis [500 mg] or placebo 3 times daily for 2 months, fasting glucose and HbA1c levels improved in the propolis treated group but not in controls; adverse events were not reported).
Lima WG, Brito JCM, da Cruz Nizer WS. (2021). Bee products as a source of promising therapeutic and chemoprophylaxis strategies against COVID-19 (SARS-CoV-2). Phytother Res. (Review of the preclinical and clinical evidence for the activity of bee products [including royal jelly, beeswax, bee pollen, bee venom and propolis] against SARS-CoV-2; no mention of adverse events).
Matsushita H, Shimizu S, Morita N, Watanabe K, Wakatsuki A. (2021). Effects of royal jelly on bone metabolism in postmenopausal women: a randomized, controlled study. Climacteric. (Among 72 postmenopausal women treated with royal jelly [3000 mg daily] or placebo for 6 months, bone mineral density did not change in those receiving royal jelly but decreased to some extent in those on placebo; no mention of adverse events).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb-induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [Fo-Ti: n=91], green tea [90], Herbalife products [64], kava kava [62], greater celandine [48] and aloe vera [22], among others; bee products were not mentioned).
Li JD, Cui L, Xu YY, Guan K. (2021). A case of anaphylaxis caused by major royal jelly protein 3 of royal jelly and its cross-reactivity with honeycomb. J Asthma Allergy. (56 year old Chinese woman developed two episodes of anaphylaxis with urticaria, pruritus, laryngeal edema, hypotension and collapse within 1 hour of consuming royal jelly and was found to have a positive skin prick test to crude extracts of royal jelly; immunoblotting with her serum identified evidence of antibodies to purified royal jelly protein 3).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3] while none were attributed to bee products).
El-Seedi HR, Eid N, Abd El-Wahed AA, Rateb ME, Afifi HS, Algethami AF, Zhao C, et al. (2022). Honey bee products: preclinical and clinical studies of their anti-inflammatory and immunomodulatory properties. Front Nutr. (Extensive review of the preclinical and clinical studies of honey bee products including royal jelly, bees wax, bee pollen and propolis; no mention of adverse event rates or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Bee Pollen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=bee+pollen+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Bee Pollen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=bee%20pollen)